# Erythromycin

## OVERVIEW

### Introduction

Erythromycin is an oral macrolide antibiotic that has been in common use since the 1950s. Erythromycin has been linked to rare instances of acute liver injury that are usually self-limited, but can result in severe injury and death.

### Background

Erythromycin (e rith" roe mye' sin) is a semisynthetic macrolide antibiotic used widely for many decades to treat mild-to-moderate bacterial infections caused by sensitive agents. Erythromycin is bacteriostatic against many gram positive bacteria including many strains of streptococci, staphylococci, clostridia, corynebacteria, listeria, haemophilus sp., moxicella, and Neisseria meningitidis. Modifications of erythromycin have been developed with a wider range of activity and less likelihood for resistance (azithromycin, clarithromycin, telithromycin). The macrolide antibiotics are believed to act by inhibiting protein synthesis of bacteria by binding to the 50S ribosomal element. Resistance occurs by several mechanisms. Erythromycin was approved for use in the United States in 1967, and currently more than 1.5 million prescriptions are filled yearly. Specific indications include mild-to-moderate upper or lower respiratory tract infections, urethritis, pelvic inflammatory disease, urogenital chlamydia infections, Legionnaires’ disease, and intestinal amebiasis. Erythromycin is commonly used as a second-line agent when penicillin, tetracyclines or metronidazole are contraindicated. Erythromycin is available in multiple formulations (estolate, ethylsuccinate, lactobionate, stearate) in many generic and brand name forms in capsules or tablets of 250 or 500 mg including enteric coated and delayed release forms. The usual adult dose is 1 to 4 grams daily in divided doses for 7 to 21 days, depending upon the type, nature and severity of the infection. Gastrointestinal side effects (abdominal pain, nausea, and diarrhea) are common, but are rarely severe.

### Hepatotoxicity

Erythromycin therapy is associated with a low rate (1% to 2%) of serum enzyme elevations during therapy. The enzyme elevations are typically asymptomatic and transient, and may occur no more frequently than with placebo or other comparator anitbiotic treatments.

Clinically apparent liver injury from erythromycin is rare, but because of the frequency of its use, erythromycin has been one of the most common causes of drug induced liver injury at least in previous years. Initially, liver injury was thought to be more common with, or perhaps limited to, erythromycin estolate. However, instances of jaundice and liver damage have been reported with virtually all formulations of erythromycin, and cross sensitivity to injury is common, although not universal. The hepatotoxicity of erythromycin resembles that described in other macrolide antibiotics and is typically a mild and self-limiting cholestatic hepatitis. The latency period between starting erythromycin and onset of liver injury is short, typically 1 to 3 weeks and is shorter (<1 week) with reexposure. Symptoms may include right upper quadrant pain and jaundice, clinical features that might suggest cholecystitis. Eosinophilia and fever are common, but not universal; rash is reported less commonly. The pattern of enzyme elevations is often mixed or variable, but the disease is usually cholestatic and symptoms of pruritus may be prominent. The liver injury is usually mild and self-limited with recovery in 4 to 8 weeks. However, instances of prolonged jaundice and cholestasis with paucity of bile ducts due to erythromycin have been reported. Furthermore, cases of abupt onset of liver injury after a short latency (<1 week) and a hepatocellular pattern of liver enzyme elevations have been reported, particularly with repeat exposure, and some of these cases have led to acute liver failure and death or need for liver transplantation. Rapid recurrence occurs with rechallenge even within 24 hours of a single dose.

A separate syndrome associated with erythromycin use is acute right upper quadrant pain without jaundice that arises within a day or two of starting therapy. Serum enzymes may be mildly elevated, usually in a hepatocellular pattern and with rapid recovery once erythromycin is stopped.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the idiosyncratic hepatitis following erythromycin therapy is not known. Allergic manifestations (rash, fever and eosinophilia) are typical, so that hypersensitivity is assumed to be the cause. Other features suggesting hypersensitivity are that rechallenge typically leads to recurrence with a shortened latency period, and patients may have a history of previous exposure to erythromycins without adverse effects.

### Outcome and Management

Most cases of erythromycin induced liver disease are mild and self-limiting; however, very rare instances of severe acute hepatic injury leading to acute liver failure and need for transplantation or death have been described. Furthermore, isolated examples of prolonged cholestasis with vanishing bile duct syndrome have been reported. Patients with erythromycin induced hepatic injury should be cautioned to avoid further exposure and it is prudent to avoid use of other macrolides in patients with clinically apparent liver injury due to erythromycin.

Drug Class: Antiinfective Agents, Macrolide Antibiotics

## CASE REPORTS

### Case 1. Abdominal pain and jaundice after erythromycin therapy.

(Modified from: Reed C, Ritchie F. Toxic jaundice due to propionyl erythromycin ester lauryl sulfate (“Ilosone”). Med J Aust 1962; 49: 810-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/14037477)

A 33 year old man with a superficial cellulitis on his hand was treated with erythromycin estolate in January 1961 and again in March. Within 10 days of starting the second course, he developed right upper quadrant abdominal pain followed by dark urine and jaundice. With stopping the drug, he improved rapidly, the pain and jaundice clearing within days (Table) and ALT levels falling to normal over the next two months. In October of the same year, he restarted erythromycin for a recurrence of the cellulitis and developed severe abdominal pain within the next day, followed shortly afterwards by jaundice and dark urine. Therapy was stopped after 2 days when he was found to be jaundiced. Again, recovery was rapid. During both episodes, there was no rash, fever, arthralgias or eosinophilia. Testing for autoantibodies was not mentioned in the report, which predated tests for hepatitis A, B and C.

#### Key Points

Medication: | Erythromycin estolate (250 mg four times daily)
Pattern: | Hepatocellular (elevations in aminotransferases only)
Severity: | 2+ (jaundiced, but not hospitalized)
Latency: | 10 days (first episode), 1 day (rechallenge)
Recovery: | Complete within 8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P* (KA U/L) | Bilirubin (mg/dL) | Other
Abdominal pain and dark urine 10 days after starting erythromycin
12 days | 0 | 3000 | 9.5 | 4.7
1 week | 2 days | 1400 | 9.0 | 0.7
3 weeks | 9 days | 350 | 7.0 | 0.6
4 weeks | 16 days | 260 | 5.0 | 0.4
6 weeks | 4 weeks | 140
7 weeks | 5 weeks | 155
8 weeks | 6 weeks | 105
10 weeks | 8 weeks | 95
Abdominal pain and dark urine within 1 day of restarting erythromycin
2 days | 0 | 3200 | 10.5 | 7.5
7 days | 5 days | 1400 | | 1.0
13 days | 11 days | 400 | | 1.2
15 days | 13 days | 170 | | 0.5
Normal Values | | <35 | <13 | <1.2

* KA U=King Armstrong Units.

#### Comment

A very convincing example of erythromycin hepatotoxicity, with symptoms arising 10 days after a second exposure to the medication and then within 24 hours of the inadvertent rechallenge 6 months later. Abdominal pain is a common presenting symptom in macrolide associated acute hepatic injury. The two episodes were mirror images in pattern and height of enzyme and bilirubin elevations. The course suggests an immunoallergic mechanism of injury, even though rash, fever and eosinophilia were absent. The symptoms and high ALT levels are typical of hepatocellular injury; but, erythromycin is classically believed to lead to cholestatic hepatitis; this example demonstrating that serum enzymes in hyperacute cases are more typically hepatocellular in pattern.

### Case 2. Asymptomatic liver injury after one day of erythromycin.

(Modified from: Alcalay J, Halevy S, Theodor E, Sandbank M. Asymptomatic liver injury due to erythromycin stearate. Drug Intell Clin Pharm 1986; 20: 601-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3743417))

A 73 year old woman was started on erythromycin stearate just before being admitted for evaluation of facial pyoderma, but was then found to have abnormal liver tests with elevations in both alkaline phosphatase and ALT (Table). Serum enzyme levels continued to climb and erythromycin was stopped, whereupon levels fell into the normal range. During the whole period, she was asymptomatic and specifically denied fatigue, nausea, abdominal pain or dark urine. Serum bilirubin levels remained normal.

#### Key Points

Medication: | Erythromycin stearate (500 mg four times daily)
Pattern: | Cholestatic (R=1.8)
Severity: | 1+ (no jaundice)
Latency: | 2 days
Recovery: | Complete within 2 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Oral erythromycin stearate started for facial pyoderma
2 days | | 125 | 178 | Normal | Asymptomatic
4 days | 0 | 210 | 240 | | Erythromycin stopped
6 days | 2 days | 140 | 230
9 days | 5 days | 115 | 175
11 days | 7 days | 70 | 140
14 days | 10 days | 60 | 120
15 days | 11 days | 35 | 110
Normal Values | | <40 | <95 | <1.2

* Some values estimated from Figure 1. Bilirubin converted from µmol (1.0 mg% = 17.1 µmol).

#### Comment

This case was unusual in several regards. First, the latency period was short, particularly for a patient who had not received erythromycin in the past. Second, the enzyme pattern was cholestatic, but there was no jaundice or symptoms. Erythromycin typically causes a syndrome of sudden onset of right upper quadrant pain, fever and jaundice. Jaundice from erythromycin is usually mild, but can occasionally be severe and prolonged. This is one of the few cases of acute erythromycin induced liver disease published in the last 25 years. This form of drug induced liver injury appears to be less common with the non-estolate forms of erythromycin, and there is a general lack of interest in publishing cases of hepatotoxicity due to drugs well known to be associated with liver injury.

### Case 3. Acute hepatitis from erythromycin.

[Modified from a case in the database of the Drug-Induced Liver Injury Network.]https://www.ncbi.nlm.nih.gov/pubmed/3743417

A 73 year old woman developed right flank pain and fever 2 to 3 days after starting erythromycin ethylsuccinate (400 mg four times daily) for symptoms of cystitis. She stopped erythromycin promptly, but developed increasing fatigue, jaundice and pruritus over the next few days and presented to her physician 4 days later. She did not drink alcohol and had no history of liver disease or risk factors for viral hepatitis. Her other medications included atorvastatin and aspirin which she had taken for many years. She had been treated with erythromycin six months previously, but without adverse effects. On admission, her serum bilirubin was 8.6 mg/dL, ALT 1884 U/L, AST 1574 U/L, alkaline phosphatase 492 U/L, serum albumin 3.2 g/dL and INR 0.85 (Table). Tests for hepatitis A, B and C were negative. Antinuclear antibody was negative, while smooth muscle antibodies were weakly positive (1:80). Abdominal ultrasound, computerized tomography and magnetic resonance cholangiopancreatography demonstrated a single large gallstone, but no evidence of biliary obstruction. She was monitored on no specific therapy and liver test abnormalities slowly improved. Symptoms resolved within two weeks, serum bilirubin fell to normal within one month and all liver tests were normal when she was seen in follow up 3 months later. Atorvastatin, which had been stopped with the onset of jaundice, was restarted without recurrence of liver injury.

#### Key Points

Medication: | Erythromycin ethylsuccinate (400 mg four times daily) for two days
Pattern: | Hepatocellular (R=13.5)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 2 days to symptoms, 4 days to jaundice
Recovery: | Complete within 3 months
Other medications: | Atorvastatin, aspirin (given chronically)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Oral erythromycin ethylsuccinate taken for 2 days for urinary tract infection
6 days | 4 days | 1884 | 492 | 8.6 | Admission
10 days | 8 days | 2058 | 626 | 7.3 | CT scan
2 weeks | 12 days | 2011 | 596 | 5.4
3 weeks | 3 weeks | 1308 | 408 | 3.1 | MRCP
4 weeks | 4 weeks | 670 | 269 | 1.9
5 weeks | 5 weeks | 263 | 191 | 1.2
6 weeks | 6 weeks | 80 | 144 | 0.9
3 months | 3 months | 32 | 78 | 0.4 | Atorvastatin restarted
10 months | 10 months | 22 | 63 | 0.7
Normal Values | | <45 | <125 | <1.2

#### Comment

The appearance of liver injury and jaundice within a week of starting erythromycin is typical of the acute onset of injury with rechallenge. This patient had taken erythromycin in the past without difficulty, but the previous exposure may have resulted in a sensitization that became clinically manifest with reexposure. The serum enzyme elevations were hepatocellular with marked increases in serum ALT and AST (40-50 times normal). However, the alkaline phosphatase was also elevated (3- to 5-fold) and she complained of pruritus during the acute episode, suggesting a cholestatic element to the injury. Erythromycin hepatotoxicity appears to be more common in older individuals. The acute, abrupt hepatocellular injury with macrolide antibiotics can be severe and lead to acute liver failure. The prompt discontinuation of the medication may have been fortunate.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Erythromycin — Generic, ERYC®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=erythromycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Erythromycin | 114-07-8 | C37-H67-N-O13 | Erythromycin structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 August 2017

Zimmerman HJ. Erythromycins. In, Zimmerman HJ. Hepatotoxicity: The adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Wilkins, 1999, pp. 594-5. (Expert review of erythromycin and liver injury published in 1999; erythromycin has been linked to many instances of cholestatic hepatitis typically presenting after 1-3 weeks of therapy [initial exposure] but sometimes within a week of starting treatment [repeat exposure] with abdominal pain [75%], jaundice [75%], fever [50%], eosinophilia [60%], and pruritus [25%], most cases being self-limiting and benign).
Moseley RH. Macrolide antibiotics. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 466-7. (Expert review of macrolide antibiotic-induced liver injury mentions that liver injury from erythromycin is typically cholestatic and usually self-limited, occurring in 3-4 persons per 100,000 users; now rarely reported).
MacDougall C, Chambers HF. Macrolides and ketolides. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1529-34. (Textbook of pharmacology and therapeutics).
Johnson DF Jr, Hall WH. Allergic hepatitis caused by propionyl erythromycin ester of lauryl sulfate. N Engl J Med 1961; 265: 1200-2. (Onset of fever and right upper quadrant pain after 12 days of erythromycin estolate [bilirubin 1.8 mg/dL, AST 117 U/L]; re-exposure caused immediate recurrence with pain [bilirubin 3.0 mg/dL, AST 320 U/L, Alk P 5 times ULN] but full subsequent recovery). 14452017
Kohlstaedt KG. Propionyl erythromycin ester lauryl sulfate and jaundice. JAMA 1961; 178: 89-90. (Letter describing 7 cases reported to Eli Lilly of jaundice, AST elevations [100-300 U/L], eosinophilia, and elevated Alk P levels after erythromycin use; 4 had positive rechallenge with pain and jaundice; after 3 years of availability, a total of 33 cases of liver injury were reported after an estimated 15 million courses: ~2 per million).
Dittler EL. Upper abdominal pain and intrahepatic cholestasis as manifestations of sensitivity to Ilosone. Am J Gastroenterol 1962; 38: 691-2. (50 year old woman had three episodes of right upper quadrant pain, fever, Alk P and ALT elevations after single erythromycin estolate ingestion: no jaundice, but few tablets taken). 14028076
Gilbert FI Jr. Cholestatic hepatitis caused by esters of erythromycin and oleandomycin. JAMA 1962; 182: 1048-50. (46 year old man developed severe right upper quadrant pain and fever 12 hours after taking 2 doses of erythromycin estolate [bilirubin 2.4 mg/dL, AST 350 U/L, Alk P 4.7 BU], but subsequently had no reaction to one challenge dose of erythromycin stearate). 13947810
Havens WP Jr. Cholestatic jaundice in patients treated with erythromycin estolate. JAMA 1962; 180: 30-2. (Report of 4 patients [ages 19-59 years, 3 men and 1 woman] with erythromycin hepatitis, latency to onset of 1-3 weeks presenting with jaundice, itching, fever and abdominal pain, 3 with eosinophilia; mixed, cholestatic and hepatocellular patterns of enzyme elevations, 3 treated with prednisone, 1 had severe and prolonged course beyond 6 months). 13905478
Masel MA. Erythromycin hepato-sensitivity: a preliminary report of two cases. Med J Aust 1962; 49: 560-2. (Two cases: 12 and 17 year old boys developed acute liver injury 11 and 17 days after starting erythromycin therapy with fever, rash, abdominal pain, jaundice [bilirubin 6.5 and 5.4 mg/dL] and eosinophilia with rapid recovery). 14470759
Reed C, Ritchie F. Toxic jaundice due to propionyl erythromycin ester lauryl sulfate (“Ilosone”). Med J Aust 1962; 49: 810-2. (33 year old man developed abdominal pain 10 days after starting erythromycin [2nd exposure] with subsequent jaundice [bilirubin 4.7 mg/dL, ALT 3000 U/L, Alk P normal], and an immediate recurrence after a single dose 6 months later; rapid recovery after both episodes: Case 1). 14037477
Riley WA. Hepatitis following administration of Ilosome. Case report. N C Med J 1962; 23: 362. (23 year old man developed fatigue after 5 days of oral erythromycin, with subsequent jaundice [bilirubin 9.6 mg/dL], resolving within a month of stopping; no serum enzyme results; had a positive rechallenge). 14038696
Robinson MM. Demonstration by "challenge" of hepatic dysfunction associated with propionyl erythromycin ester lauryl sulfate. Antibiot Chemother 1962; 12: 147-51. (Follow up study, triacetyloleandomycin led to raised ALT in 11 of 59 patients treated for more than 14 days; rechallenge in 3 led to increases in ALT to 340, 81 and 274 U/L with eosinophilia [6-11%] but no jaundice). 14492925
Robinson MM. Hepatic dysfunction associated with triacetyloleandomycin and propionyl erythromycin ester lauryl sulfate. Am J Med Sci 1962; 243: 502-10. (Prospective study of 80 patients receiving erythromycin estolate, 10 developed raised ALT [67-300 U/L] within 14-21 days, 2 had jaundice [2.2 and 3.5 mg/dL], all resolved with stopping but 3/3 had ALT rise [180-2060 U/L] and eosinophilia within 24 hours of rechallenge). 14492926
Robinson MM. Hepatic dysfunction associated with triacetyloleandomycin demonstrated by challenge. Am J Med Sci 1962; 244: 221-4. (Follow up study, triacetyloleandomycin led to raised ALT in 11 of 59 patients treated for more than 14 days; rechallenge in 3 led to increases in ALT to 340, 81 and 274 U/L with eosinophilia [6-11%] but no jaundice). 14492927
Brown AR. Two cases of untoward reaction after "Ilosone". Br Med J 1963; 2: 913-5. (2 case reports from Australia: 25 year old man developed fever, severe right upper quadrant pain and jaundice that persisted for 3 months after 2nd day of a second 3-day course of erythromycin estolate; 51 year old woman developed acute right upper quadrant pain after single dose of erythromycin [bilirubin normal, AST 95 U/L, Alk P 22 KA U/L], resolving within 3 weeks). 14067683
Farmer CD, Hoffman HN 2nd, Shorter RG, Thurber DL, Bartholomew LG. Intrahepatic cholestasis associated with the ingestion of erythromycin estolate (Ilosone). Gastroenterology 1963; 45: 158-60. (6 cases of erythromycin hepatotoxicity from Mayo Clinic with onset after 6-21 days, usually presenting with abdominal pain and fever but mild jaundice, rapid recovery; 2 patients had previous exposures, 1 had positive rechallenge). 14054883
Ticktin HE, Robinson MM. Effects of some antimicrobial agents on the liver. Ann NY Acad Sci 1963; 104: 1080-92. (Not in PubMed).
Fischer HW, Hoak JC. Mimicry of acute cholecystitis by erythromycin estolate reactions. Report of 2 cases. Am J Med Sci 1964; 247: 283-5. (Two men (ages 42 and 53 years] developed acute right upper quadrant pain after 4 and 2 days of oral erythromycin with minimal ALT increase and no jaundice or gallstones, 1 had rapid recurrence with rechallenge). 14130320
Fukayak TG. [Case of hypersensitive hepatitis due to propionyl erythromycin lauryl sulfate] Naika 1964; 14: 741-4. Japanese. 14202924
Nilsson S. [Liver disorders due to treatment with propionyl-erythromycin-lauryl sulfate (Ilosone)] Nord Med 1964; 72: 1417-9. Swedish. 14227583
Herskovic T, Solis J, Villasana Z, Jinich H. Acute abdomen associated with the ingestion of erythromycin estolate. Am J Gastoenterol 1965; 43: 138-142.
McKenzie I, Doyle A. Two cases of jaundice following "Ilosone". Med J Aust 1966; 1: 349-51. (Two cases: 40 and 21 year old men developed jaundice after 4 and 8 days of therapy with erythromycin estolate [bilirubin 6 and 12 mg/L, AST 80 and 87 U/L, Alk P 47 and 15 U/L], with slow recovery [1 and 6 months]). 5906690
Petricević I, Kosutić Z, Schönwald S, Rulnjević J. [Hepatitis caused by erythromycin] Lijec Vjesn 1968; 90: 1051-9. Croatian. 5195777
Braun P. Hepatotoxicity of erythromycin. J Infect Dis 1969; 119: 300-6. (Thorough review of literature on hepatotoxicity of macrolides up to 1969: by then, there were 45 published cases of liver injury from erythromycin estolate [none with stearate] presenting within 1-3 weeks with jaundice [67%], abdominal pain, nausea and fever [~50%] as well as eosinophilia [62%], elevations in ALT [100%: average 338 U/L] and Alk P [51%]; 13 rechallenged, invariably followed by rapid recurrence, often severe]) 4888905
Kosenow W, Stollenwerk F. [Jaundice following erythromycin-estolate therapy] Dtsch Med Wochenschr 1971; 96: 1836 passim. German. 5121113
Oliver LE, Iser JH, Stening GF, Smallwood RA. Abdominal pain and erythromycin estolate. Lancet 1972; 2: 980. (Letter describing 5 cases of severe right upper quadrant pain within 4-36 hours of taking erythromycin estolate, 2 with jaundice). 4116869
The erythromycins. A further report from the Australian Drug Evaluation Committee. Med J Aust 1973; 2: 192-3. (As of May 1973, 113 cases of jaundice due to erythromycin estolate had been reported to Australian registry; all ages affected, mostly within 14 days, but some >21 days of starting, usually lasting < 28 days, no deaths). 4741351
[Erythromycin estolate and liver toxicity] Ugeskr Laeger 1974; 136: 2093-4. Danish. 4409491
Buchanec J, Krajnák V. [Liver damage during erythromycin therapy in 3 children] Cesk Pediatr 1974; 29: 76-8. Slovak. 4452168
Tolman KG, Sannella JJ, Freston JW. Chemical structure of erythromycin and hepatotoxicity. Ann Intern Med 1974; 81: 58-60. (Patient with erythromycin estolate hepatotoxicity was rechallenged with various erythromycins: rapid recurrence after estolate [temp 39.9° C, bilirubin 2.3 mg/dL, ALT 608 U/L], within 5 days and after propionate [temp 38.4° C, bilirubin 1.7 mg/dL, ALT 326 U/L] but no recurrence after stearate, ethylsuccinate or erythromycin-base rechallenges). 4834945
Lunzer MR, Huang SN, Ward KM, Sherlock S. Jaundice due to erythromycin estolate. Gastroenterology 1975; 68(5 Pt 1): 1284-91. (43 year old man developed right upper quadrant pain 24 hours after starting a second course of erythromycin estolate followed by jaundice; rechallenged and redeveloped pain [AST rising from 12 to 302 U/L, Alk P 11 to 22 KA U, bilirubin 0.5 to 1.3 mg/dL]: biopsy before and after rechallenge showed inflammation and endoplasmic reticulum changes by electron microscopy without necrosis). 1126604
Pessayre D, Marie C, Benhamou JP. [Hepatitis due to erythromycin propionate (author's transl)] Arch Fr Mal App Dig 1976; 65: 405-8. French. (Cholestatic jaundice with right upper quadrant pain and eosinophilia, resolving with stopping erythromycin propionate and recurring with rechallenge). 1008656
Cacace LG, Schweigert BF, Gildon AM. Erythromycin estolate induced hepatotoxicity: report of a case and review of the literature. Drug Intell Clin Pharm 1977; 11: 22-25. Not in PubMed.
Cooksley WG, Powell LW. Erythromycin jaundice: diagnosis by an in vitro challenge test. Aust N Z J Med 1977; 7: 291-3. (53 year old woman developed fever within 24 hours and jaundice within 4 days of taking 2 capsules of erythromycin estolate [bilirubin 17.1 mg/dL, AST 69 U/L, Alk P 114 U/L] and recovery in ~3 weeks; lymphocyte transformation tests was positive 2 years later to estolate but not stearate or erythromycin base). 269690
McCormack WM, George H, Donner A, Kodgis LF, Alpert S, Lowe EW, Kass EH. Hepatotoxicity of erythromycin estolate during pregnancy. Antimicrob Agents Chemother 1977; 12: 630-5. (Prospective study comparing safety and efficacy of erythromycin estolate, clindamycin and placebo for 6 weeks in 539 pregnant women with genital mycoplasma infections; AST elevations occurred in 10% with erythromycin [44-130 U/L], vs 2.4% with clindamycin [42-44 U/L] and 1.8% with placebo [42-88 U/L]; lower rates subsequently with stearate [3.0%]). 21610
Lloyd-Still JD, Sherman JO, Boggs J, Demers LM. Erythromycin estolate hepatotoxicity. Am J Dis Child 1978; 132: 320. (7 year old boy developed fever and severe right upper quadrant pain within 24 hours of re-exposure to erythromycin estolate [bilirubin 4.8 mg/dL, AST 150 U/L, Alk P 90 U/L, bile acids >100 fold increased]). 629252
Rodríguez Cuartero A, Rodríguez Cuartero F, Alonso Fernández J, Castillo Higueras PL. [Acute hepatitis caused by erythromycin] Rev Esp Enferm Apar Dig 1978; 54: 533-6. Spanish. (29 year old pregnant woman had onset of abdominal pain and nausea within days of starting erythromycin, followed by miscarriage at 10 days and jaundice at two weeks [bilirubin 7.2 mg/dL, ALT 214 U/L, Alk P not done]; resolving within 1 month). 746229
Gafter U, Mandel EM, Weiss S, Djaldetti M. Erythromycin estolate-induced hepatitis. Ultrastructural study of liver. N Y State J Med 1979; 79: 87-9. (28 year old woman developed abdominal pain, fever and jaundice after 2 weeks of erythromycin estolate [12% eosinophils, bilirubin 3.7 mg/dL, ALT 175 U/L, Alk P 2 times ULN], recurring within 1 day of rechallenge with one pill [bilirubin 2.8 mg/dL], biopsy showing mild changes of cholestasis by electron microscopy with dilated canaliculi). 282477
Krowchuk D, Seashore JH. Complete biliary obstruction due to erythromycin estolate administration in an infant. Pediatrics 1979; 64: 956-8. (6 week old infant developed jaundice and acholic stools starting 6 days after course of erythromycin estolate which resolved after passing of "green plug" in stool). 514726
Pessayre D, Benhamou JP. Hepatotoxicity of erythromycin derivatives. Br Med J 1979; 1: 1357. (Letter in response to review that suggested that only the estolate form of erythromycin causes liver injury: argues that this is not correct). 445081
Viteri AL, Greene JF Jr, Dyck WP. Erythromycin ethylsuccinate-induced cholestasis. Gastroenterology 1979; 76 (5 Pt 1): 1007-8. (Initial report of liver toxicity of ethylsuccinate, 52 year old woman developed abdominal pain 1 day after starting erythomycin ethylsuccinate, followed by fever and jaundice [AST 54 U/L, Alk P 178 U/L, bilirubin 4.8 mg/dL, GGT 197 U/L] resolving 5 weeks later; history was later obtained of similar episode with previous exposure to erythromycin). 437404
Zafrani ES, Ishak KG, Rudzki C. Cholestatic and hepatocellular injury associated with erythromycin esters: report of nine cases. Dig Dis Sci 1979; 24: 385-96. (Review of histology of 9 cases of erythromycin liver injury from Armed Forces Institute of Pathology files; mostly cholestatic or mixed enzyme pattern, all self-limited, [bilirubin 2.1-12 mg/dL, ALT 128-560 U/L, Alk P 2-12 times ULN]; liver histology showed cholestasis and hepatocellular injury). 456225
Sullivan D, Csuka ME, Blanchard B. Erythromycin ethylsuccinate hepatotoxicity. JAMA 1980; 243: 1074. (45 year old woman developed cholecystitis-like clinical picture with fever and eosinophilia 9 days after starting erythromycin ethylsuccinate [ALT rising to 613 U/L, Alk P 190 U/L but no jaundice], resolving rapidly after stopping). 6965509
Bachman BA, Boyd WP Jr, Brady PG. Erythromycin ethylsuccinate-induced cholestasis. Am J Gastroenterol 1982; 77: 397-400. (49 year old woman with recurrent episodes of right upper quadrant pain and cholestatic jaundice caused by intermittent use of erythromycin ethylsuccinate, reproduced within 1 day of deliberate rechallenge [bilirubin 2.2 mg/dL, ALT 243 U/L, Alk P 438 U/L]). 6979924
Cocchi P, Silenzi M, Salvi G, Calabri G, Tamburini M, Alvisi P. [Hepatotoxic syndrome caused by erythromycin ethyl succinate] Minerva Pediatr 1982; 34: 68-9. Italian. 6978458
Funck-Brentano C, Danan G, Pessayre D, Benhamou JP. [Hepatitis due to erythromycin ethylsuccinate] Gastroenterol Clin Biol 1982; 6: 1044-5. French. (48 year old man developed fatigue after 9 and jaundice after 11 days of oral erythromycin ethylsuccinate [bilirubin 12.9 mg/dL, ALT 360 U/L, Alk P 2.5 times ULN] and prolonged jaundice [2 months] with slow recovery [drug not stopped promptly]). 6984402
Keeffe EB, Reis TC, Berland JE. Hepatotoxicity to both erythromycin estolate and erythromycin ethylsuccinate. Dig Dis Sci 1982; 27: 701-4. (Two cases of erythromycin estolate liver injury with rapid recurrence on exposure to ethylsuccinate 13-15 years later; cholecystitis-like syndrome with abdominal pain and fever [peak AST 63 and 500 U/L, Alk P 99 and 159 U/L). 6980110
Ponsot P, Théodore C, Larrey D, Breil P, Hugentobler JP, Paolaggi JA. [Acute hepatitis caused by erythromycin propionate] Gastroenterol Clin Biol 1982; 6: 594. French. (Third reported case of hepatitis from erythromycin propionate; 58 year old man developed abdominal pain and fever within 8 hours of taking drug [bilirubin 2.7 mg/dL, ALT 55 U/L, Alk P 5.4 times ULN], resolving within 1 week of stopping). 7117770
Funck-Brentano C, Pessayre D, Benhamou JP. [Hepatitis caused by various derivatives of erythromycin] Gastroenterol Clin Biol 1983; 7: 362-9. French. 6347792
Hosker JP, Jewell DP. Transient, selective factor X deficiency and acute liver failure following chest infection treated with erythromycin BP. Postgrad Med J 1983; 59: 514-5. (57 year old man developed "acute liver failure" and coagulopathy arising after 6 days of therapy with oral erythromycin base [bilirubin 2.0 mg/dL, AST 61 U/L, Alk P 866 U/L, protime 19.6 seconds], with eventual recovery). 6622343
Inman WH, Rawson NS. Erythromycin estolate and jaundice. Br Med J (Clin Res Ed) 1983; 286: 1954-5. (Survey of ~5000 physicians using erythromycin in UK during 2 months of 1982, 3 reports of jaundice attributable to drug, all due to erythromycin stearate). 6407653
Paliard P, Stremsdoerfer N, Moindrot H. [Acute hepatitis caused by erythromycin esters (propionate and ethylsuccinate)] Gastroenterol Clin Biol 1983; 7: 100-1. French. (54 year old man developed cholecystitis-like syndrome after 15 days of erythromycin propionate; 2 years later patient received erythromycin ethylsuccinate and developed fever and jaundice 7 days later [bilirubin 3.8 mg/dL, ALT 194 U/L, Alk P 148 U/L], resolving within 3 weeks; then had positive response to deliberate rechallenge with propionate with fever and ALT rising to 323 U/L in 24 hours). 6601598
Phillips KG. Hepatotoxicity of erythromycin ethylsuccinate in a child. Can Med Assoc J 1983; 129: 411-2. (9 year old boy developed right upper quadrant pain after 7 days of erythromycin ethylsuccinate therapy [bilirubin 3.1 mg/dL, AST 258 U/L, Alk P 424 U/L], resolving within 15 days of stopping). 6603894
Diehl AM, Latham P, Boitnott JK, Mann J, Maddrey WC. Cholestatic hepatitis from erythromycin ethylsuccinate. Am J Med 1984; 76: 931-4 (46 and 54 year old women developed acute cholestatic hepatitis from erythromycin ethylsuccinate with latency of 2 and 6 days [with previous exposures] and ALT 98-405 U/L, Alk P 206-234 U/L [normal <33], and recovery within 2-6 weeks). 6609640
Ortuño JA, Olaso V, Berenguer J. [Cholestasis hepatitis caused by erythromycin propionate] Med Clin (Barc) 1984; 82: 912. Spanish. (38 year old woman developed fever followed by jaundice and pruritus 15 days after starting erythromycin propionate [bilirubin 11.9 mg/dL, ALT 128 U/L, Alk P 246 U/L]; biopsy showed intrahepatic cholestasis, resolved within 5 weeks of stopping). 6748800
Patel J, Schneider R. Hepatotoxic reaction to erythromycin ethylsuccinate. South Med J 1984; 77: 1343-4. (70 year old woman developed fatigue after 2 weeks of erythromycin ethylsuccinate therapy [bilirubin 1.3 mg/dL, ALT 254 U/L, Alk P 314 U/L] with rapid recovery upon stopping). 6333077
García Monzón C, Noguerado A, Hidalgo S, Escudero V. [Cholestatic hepatitis caused by erythromycin estolate] Rev Clin Esp 1985; 177: 420-1. Spanish. 3836470
Pessayre D, Larrey D, Funck-Brentano C, Benhamou JP. Drug interactions and hepatitis produced by some macrolide antibiotics. J Antimicrob Chemother 1985; 16 Suppl A: 181-94. (Review of hepatic effects of macrolides: 55 published cases of hepatitis from estolate, 10 from ethylsuccinate, and 3 from propionate; usually with a mixed enzyme pattern, fever in 59%, eosinophilia in 45%, “outcome is always favorable”). 3877043
Simon C, Roul G, Chabrier G, Schlienger JL, Imler M. [Hepatic involvement induced by erythromycin propionate] Rev Med Interne 1985; 6: 84-5. French. 4001646
Alcalay J, Halevy S, Theodor E, Sandbank M. Asymptomatic liver injury due to erythromycin stearate. Drug Intell Clin Pharm 1986; 20: 601-2. (73 year old woman found to have enzyme elevations [bilirubin normal, ALT 126 U/L, Alk P 178 U/L] 36 hours after starting erythromycin stearate, resolving with stopping drug within 2 weeks; no symptoms or jaundice: Case 2). 3743417
Swayne LC, Kolc J. Erythromycin hepatotoxicity. A rare cause of a false-positive technetium-99m DISIDA study. Clin Nucl Med 1986; 11: 10-2. (39 year old woman developed abdominal pain and fever after 3 days of erythromycin estolate therapy [bilirubin 1.9 mg/dL, ALT 417 U/L, Alk P 250 U/L] and abnormal hepatobiliary radiotracer scan, but normal on follow up). 3943237
Perrier M, Portier G, de Calan L, et al. [Erythromycin-induced hepatitis] Cah Anesthesiol 1987; 35: 237. French. 3621021
Geubel AP, Nakad A, Rahier J, Dive C. Prolonged cholestasis and disappearance of interlobular bile ducts following chlorpropamide and erythromycin ethylsuccinate. Case of drug interaction? Liver 1988; 8: 350-3. (52 year old man developed vanishing bile duct syndrome leading to cirrhosis and death 2 years later, which arose after an acute cholestatic hepatitis with fever, rash and eosinophilia [bilirubin 8.0 mg/dL, ALT 159 U/L, Alk P 1156 U/L] after 3 weeks of erythromycin ethylsuccinate therapy, but also 4 months after starting chlorpropamide). 3265170
Luherne JY, Pariente EA, Maitre F. [Crossed hepatotoxicity of erythromycin propionate and troleandomycin?] Gastroenterol Clin Biol 1988; 12: 869-70. French. 3265396
Rigauts HD, Selleslag DL, Van Eyken PL, Van Damme BJ, Fevery JM, Marchal GJ. Erythromycin-induced hepatitis: simulator of malignancy. Radiology 1988; 169: 661-2. (67 year old woman developed jaundice and pruritus 2 weeks after starting erythromycin estolate [bilirubin 2.3 mg/dL, ALT 219 U/L, Alk P 180 U/L] with liver-spleen scan showing changes suggestive of multiple metastases, biopsy showing cholestatic hepatitis and repeat scan 10 weeks later was normal). 3055031
Dubois A, Nakache N, Raffanel C, Balmes JL. [Acute cholestatic hepatitis after ingestion of roxithromycin] Gastroenterol Clin Biol 1989; 13: 317-8. French. (58 year old woman developed jaundice 4 days after starting a 5-day course of roxithromycin [introduced in France in 1987] with bilirubin 4.9 mg/dL, Alk P 442 U/L, ALT 46 U/L, and full recovery within 2 months of stopping). 2731688
García Buey L, García-Samaniego Rey J, González Estecha A, Pajares García JM. [Hepatotoxicity of erythromycin] Rev Clin Esp 1989; 184: 158. Spanish. 2785700
Alemayehu G, Näslund I. [Erythromycin caused liver injury and gallbladder inflammation] Lakartidningen 1990; 87: 2866. Swedish. 2215004
Bojarska-Dahlig H. Hepatotoxicity of macrolide antibiotics. J Antimicrob Chemother 1990; 25: 475-7. (Discussion of relative rates of liver injury in rats based upon molecular weight and erythromycin equivalents). 2338425
Delcourt A, Lambert M, Brenard R, Geubel A. Reversible liver injury possibly due to roxithromycin therapy. Acta Clin Belg 1990; 45: 206-7. (Second case of roxithromycin-induced liver injury, in a 43 year old man with onset of jaundice after 1 week of therapy [bilirubin 3.5 mg/dL, ALT 147 U/L, Alk P 477 U/L, GGT 950 U/L], resolving within 3 weeks of stopping). 2166418
de Escalante B, Sampedro JA, Zabala S, Gracia P. [Cholestatic hepatitis caused by erythromycin propionate] An Med Interna 1990; 7: 656. Spanish. 2135589
Gholson CF, Warren GH. Fulminant hepatic failure associated with intravenous erythromycin lactobionate. Arch Intern Med 1990; 150: 215-6. (72 year old man developed liver injury after 7 days of iv erythromycin therapy [bilirubin 3.0 mg/dL rising to 14.1 mg/dL, AST 450 rising to 1420 U/L, Alk P 108 U/L] with rapid progression to liver failure and death within a week). 2297290
Serrano Heranz R, Ziad F. [Hepatotoxicity caused by erythromycin ethylsuccinate] An Med Interna 1990; 7: 215. Spanish. 2103790
Caballeria Rovira E, Arago López JV, Masso Ubeda RM, Sanchis Closa A. [Hepatotoxicity due to erythromycin ethylsuccinate] Rev Esp Enferm Dig 1991; 80: 356. Spanish. 1768482
Lehtonen L, Lankinen KS, Wikberg R, Rita H, Salmi HA, Valtonen V. Hepatic safety of erythromycin acistrate in 1549 patients with respiratory tract or skin infections. J Antimicrob Chemother 1991; 27: 233-42. (Post-marketing evaluation of enzyme elevations during 7-14 day courses of erythromycin acistrate, a prodrug: ALT elevations occurred in ~8% before and ~15% after the courses, usually mild and transient; only 3 [0.2%] attributed to drug). 1676027
Degott C, Feldmann G, Larrey D, Durand-Schneider AM, Grange D, Machayekhi JP, Moreau A, et al. Drug-induced prolonged cholestasis in adults: a histological semiquantitative study demonstrating progressive ductopenia. Hepatology 1992; 15: 244-51. (Clinical and histological description of drug-induced prolonged cholestasis and ductopenia, the severe form of which can lead to vanishing bile duct syndrome, cirrhosis and hepatic failure: 8 cases with 3 due to ajmaline and one each to cyamemazine, troleandomycin, erythromycin, amitriptyline, and cyproheptadine). 1735527
Saiz Santos S, Montero López L. [Hepatotoxicity from erythromycin estolate] Aten Primaria 1992; 10: 1050. Spanish. 1467424
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119(7 Pt 1): 576-83. (In Medicaid records between 1980-87, 107 patients were hospitalized for acute hepatitis of unknown cause, 5 [4.7%] of whom had received erythromycins compared to 0.9% of controls. No case received estolate). 8363168
Derby LE, Jick H, Henry DA, Dean AD. Erythromycin-associated cholestatic hepatitis. Med J Aust 1993; 158: 600-2. (Retrospective cohort study of 366,064 people who received erythromycin in UK database, found 13 cases of cholestatic hepatitis of uncertain cause within 45 days of prescription: risk=3.6/100,000 similar for ethylsuccinate and base preparations [estolate and stearate rarely used]: risk increased with age and was independent of sex). 8479375
Esteban A, Molina MJ, Soto C, Hernández G. [Acute cholestatic hepatitis due to roxithromycin] Rev Clin Esp 1993; 192: 352-3. Spanish. 8497745
Gross R, Mion F, Paliard P. [Cholestasis induced by roxithromycin in a patient with a past history of pregnancy intrahepatic cholestasis] Gastroenterol Clin Biol 1993; 17: 146-7. French. 8500706
Howe E, Howe E, Benn RA. Hepatotoxicity due to erythromycin ethylsuccinate. Med J Aust 1993; 158: 142-4. (3 adults with fever and right upper quadrant pain, 2 with jaundice, within few days of starting erythromycin ethylsuccinate, [with history of previous exposures] similar syndrome to that of estolate). 8419773
Pedersen FM, Bathum L, Fenger C. Acute hepatitis and roxithromycin. Lancet 1993; 341: 251-2. (23 year old woman developed jaundice and fever after 4 days of roxithromycin therapy [bilirubin 7 mg/dL, ALT 4630 U/L, protime 17%], resolving within 3 weeks; possible contribution of acetaminophen use). 8093543
Danan G, Bénichou C. Roxithromycin-induced or herpes hepatitis? Lancet 1993; 341: 896-7. (Letter from manufacturer in response to Pederson et al questioning the role of roxithromycin). 8096597
Pérez Gutthann S, García Rodríguez LA. The increased risk of hospitalizations for acute liver injury in a population with exposure to multiple drugs. Epidemiology 1993; 4: 496-501. (Case control study from Canadian Health Plan records, 1982-6, risk of hospitalization for liver injury was 1/100,000 for NSAIDs and 14/100,000 for erythromycin estolate [no case related to other types of erythromycin] and risk increased if multiple known hepatotoxins were used). 8268277
Periti P, Mazzei T, Mini E, Novelli A. Adverse effects of macrolide antibacterials. Drug Saf 1993; 9: 346-64. (Extensive review of literature on adverse events reported with macrolide antibiotics). 8280403
Ducloux D, Welker Y, Modai J. [Pseudo-cholangitis, a form of erythromycin-induced hepatitis] Presse Med 1995; 24: 1663. French. 8545387
Gilbert FI Jr. Cholestatic hepatitis caused by esters of erythromycin and oleandomycin. 1962. Hawaii Med J 1995; 54: 603-5. 7642362
Hautekeete ML. Hepatotoxicity of antibiotics. Acta Gastroenterol Belg 1995; 58: 290-6. (Review of hepatotoxicity associated with antibiotics; the erythromycins are mentioned as well known to cause cholestatic hepatitis). 7491842
Tomei F, Iavicoli S, Iavicoli A, Papaleo B, Baccolo TP. Liver damage in pharmaceutical industry workers. Arch Environ Health 1995; 50: 293-7. (Study of 40 Italians working in a pharmaceutical plant producing erythromycin found 37% to have elevated ALT levels compared to 6% in controls working elsewhere; no frank hepatitis or markedly elevated values). 7677429
von Rosensteil NA, Adam D. Macrolide antibacterials. Drug interactions of clinical significance. Drug Saf 1995; 13: 105-22. 7576262
George DK, Crawford DH. Antibacterial-induced hepatotoxicity. Incidence, prevention and management. Drug Saf 1996; 15: 79-85. (Review of hepatotoxicity of antibiotics including macrolides from Australia). 8862966
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years experience. N Z Med J 1996; 109: 315-9. (Erythromycin ranked 1st as a cause of liver adverse drug reactions in New Zealand from 1974 to 1995, accounting for ~12% of cases). 8816722
Viluksela M, Vainio PJ, Tuominen RK. Cytotoxicity of macrolide antibiotics in a cultured human liver cell line. J Antimicrob Chemother 1996; 38: 465-73. (In vitro study of cytotoxicity of macrolides). 8889721
Vial T, Biour M, Descotes J, Trepo C. Antibiotic-associated hepatitis: update from 1990. Ann Pharmacother 1997; 31: 204-20. (Extensive review including discussion of macrolides [erythromycin, clarithromycin and azithromycin]; ALT elevations occur in 0.4-1.2% of patients treated with macrolides but similar rates found in placebo controls; rare instances of cholestatic hepatitis attributed to all three). 9034423
Wong PW, Dillard TA, Kroenke K. Multiple organ toxicity from addition of erythromycin to long-term lovastatin therapy. South Med J 1998; 91: 202-5. (73 year old man on long term lovastatin therapy developed rhabdomyolysis [CPK 4235 U/L, AST 476 U/L, ALT 236 U/L, bilirubin 1.1 mg/dL, GGT 30 U/L] after receiving 2 weeks of erythromycin [which may have altered the metabolism of the statin causing elevated levels and muscle injury]; renal failure occurred but patient ultimately recovered). 9496876
Horn S, Aglas F, Horina JH. Cholestasis and liver cell damage due to hypersensitivity to erythromycin stearate--recurrence following therapy with erythromycin succinate. Wien Klin Wochenschr 1999; 111: 76-7. (Woman developed cholestatic hepatitis after both erythromycin stearate and succinate). 10081126
Principi N, Esposito S. Comparative tolerability of erythromycin and newer macrolide antibacterials in paediatric patients. Drug Saf 1999; 20: 25-41. 9935275
Lazarczyk DA, Duffy MC. Erythromycin-induced primary biliary cirrhosis. Dig Dis Sci 2000; 45: 1115-8. (48 year old woman developed jaundice and pruritus 3 weeks after an 8-day course of erythromycin [bilirubin 4.1 mg/dL, ALT 249 U/L, Alk P 336 U/L] with rapid resolution but finding of mitochrondial antibody [AMA] and persistence of mildly abnormal liver enzymes [bilirubin 0.2 mg/dL, ALT 58 U/L, Alk P 120 U/L] led to a liver biopsy 6 months later that showed primary biliary cirrhosis). 10877225
Chitturi S, Farrell GC. Drug-induced cholestasis. Semin Gastrointest Dis 2001; 12: 113-24. (Review of cholestatic forms of drug-induced liver disease with case report of 70 year old man who developed prolonged jaundice and pruritus starting 8 weeks after a 1-week course of erythromycin base [bilirubin 18 mg/dL, ALT 62 U/L, Alk P 277 U/L]; liver biopsy showing fibrosis and duct paucity at 18 months and ultimate clinical recovery despite persistence of mild Alk P elevations for 10 years thereafter). 11352118
Easton-Carter KL, Hardikar W, Smith AL. Possible roxithromycin-induced fulminant hepatic failure in a child. Pharmacotherapy 2001; 21: 867-70. (5 year old child developed fever and rash 1 day after 5- day course of roxithromycin followed by jaundice [bilirubin 17 mg/dL, ALT 1912 U/L, Alk P 480 U/L] progressing to hepatic failure requiring liver transplantation). 11444584
Pari L, Uma A. Protective effect of Sesbania grandiflora against erythromycin estolate-induced hepatotoxicity. Therapie 2003; 58: 439-43. (Study of prevention of erythromycin hepatic injury in rats with herbals). 14682193
Akcay A, Kanbay M, Sezer S, Ozdemir FN. Acute renal failure and hepatotoxicity associated with roxithromycin. Ann Pharmacother 2004; 38: 721-2. (73 year old woman developed fever and arthralgias after 2 days of roxithromycin therapy followed by renal insufficiency [creatinine 3.9 mg/dL, bilirubin not given, ALT 225 U/L, GGT 227 U/L, 25% eosinophilia], resolving within 1 week without dialysis). 14766998
Pari L, Murugan P. Protective role of tetrahydrocurcumin against erythromycin estolate-induced hepatotoxicity. Pharmacol Res 2004; 49: 481-6. (Study of prevention of hepatic injury in rats with anti-oxidants). 14998559
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Review of fatal adverse drug event reports of liver injury in Sweden between 1966 and 2002, found 103 cases, one attributed to erythromycin). 16165719
Karthik SV, Casson D. Erythromycin-associated cholestatic hepatitis and liver dysfunction in children: the British experience. J Clin Gastroenterol 2005; 39: 743-4. (10 year old girl developed abdominal pain within a day of starting erythromycin ethylsuccinate therapy followed by jaundice [bilirubin 14.1 mg/dL, ALT 278 U/L, GGT 4 times ULN], resolving within 8 weeks of stopping). 16082288
Chang CY, Schiano TD. Drug hepatotoxicity. Aliment Pharmacol Ther 2007; 25: 1135-51. (Review article summarizing large cohort studies in which erythromycin or the macrolides were often among the most common causes of liver injury). 17451560
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug-induced liver disease in the U.S. collected from 2004 to 2008, 5 cases were attributed to telithromycin and 3 to azithromycin as single agents but none to erythromycin or clarithromycin). 18955056
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: pathomechanisms and clinical data. Infection 2010; 38; 3-11. (Review; the macrolide antibiotics may cause cholestatic hepatitis at an estimated rate of 3.6 for erythromycin, 3.8 for clarithromycin, and 5.5 cases per 100,000 prescriptions for telithromycin, compared to 10 for sulfonamides and 2000 per 100,000 for isoniazid). 20107858
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 63 cases attributed to azithromycin, 60 to erythromycin and 35 to clarithromycin). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 31 were due to antibiotics, but none were attributed to erythromycin). 20949552
Lee CH, Wang JD, Chen PC; Health Data Analysis in Taiwan (hDATa) Research Group. Case-crossover design: an alternative strategy for detecting drug-induced liver injury. J Clin Epidemiol 2012; 65: 560-7. (Analysis of the Taiwan National Health Insurance database from 1997 to 2004 found an adjusted odds ratio of 2.1 to 2.5 for hospitalization, with unexplained liver injury within 30 days of a prescription for erythromycin). 22445086
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to erythromycin or other macrolide antibiotics). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, one of which was attributed to clarithromycin [acute liver failure], but none were attributed to erythromycin). 24552865
Ferrajolo C, Coloma PM, Verhamme KM, Schuemie MJ, de Bie S, Gini R, Herings R, et al.; EU-ADR consortium. Signal detection of potentially drug-induced acute liver injury in children using a multi-country healthcare database network. Drug Saf 2014; 37: 99-108. (Analyses of large spontaneous reporting databases from 3 European countries between 1995 and 2010 identified 125 drugs with at least one exposed case of unexplained acute liver injury in children, 20 of which had a statistically significant association, including clarithromycin [5 cases] and erythromycin [4 cases], but not azithromycin). 24446276
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 29 due to marolides, of which 18 were linked to azithromycin, 2 clarithromycin, 2 erythromycin and 7 telithromycin: Case 3). 25754159
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf 2017; 40: 305-15. (In a health care database of 429,772 children in Italy and the Netherlands followed between 2008 and 2010, 938 cases of liver injury of uncertain cause were identified, the rate being higher in those with current use of antibiotics [12% vs 3.6%] for an adjusted odds rate ratio [aOR] of 3.2; specific antibiotics most commonly implicated were fluoroquinolones [19.0], cephalosporins [4.5], macrolides [3.5] and penicillins [2.6]; no specific mention of erythromycin). 28025733

## OTHER REFERENCE LINKS

1. Recent References on Erythromycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=erythromycin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222007/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Erythromycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=erythromycin)